# Thiotepa

## OVERVIEW

### Introduction

Thiotepa is an intravenously or locally applied alkylating agent which is currently used in the therapy of breast, ovarian and bladder cancer. Thiotepa therapy has been associated with low rates of serum enzyme elevations during therapy and rare instances of acute, clinically apparent injury.

### Background

Thiotepa (thye' oh tep' a) is an ethylenimine similar in structure and activity to altretamine and is believed to act as an alkylating agent. The alkylating agents act by causing modification and cross linking of DNA, thus inhibiting DNA, RNA and protein synthesis and causing programmed cell death (apoptosis) in rapidly dividing cells. Thiotepa was approved for use in the United States in 1959. Current indications include ovarian and breast cancer and Hodgkin disease. Thiotepa is also administered locally for bladder cancer, neoplastic effusions and malignant meningeal neoplasms. Thiotepa is available generically in vials of 15 mg. The recommended dose varies by indications, route of administration, and body weight. Thiotepa shares common side effects with other alkylating agents such as nausea, vomiting, diarrhea, alopecia, mucositis, bone marrow suppression, rash and hypersensitivity reactions. Uncommon but potentially serious adverse events include severe myelosuppression, severe infections, sepsis, bleeding, and embryo-fetal toxicity.

### Hepatotoxicity

Thiotepa is associated with an appreciable rate of serum enzyme elevations during therapy, but these are generally mild and self-limited, not requiring dose adjustment. Rare instances of clinically apparent acute liver injury attributed to thiotepa have been reported, particularly with high doses. In most instances, thiotepa was administered in combination with other agents known to cause liver injury and the specific role of thiotepa was not clear.

Thiotepa is often used in combination with other alkylating agents in conditioning regimens for bone marrow ablation in preparation for hematopoietic cell transplantation and as such has been linked to instances of sinusoidal obstruction syndrome. Onset of sinusoidal obstruction syndrome is usually within 1 to 3 weeks of myeloablative or high dose therapy and is characterized by the sudden development of abdominal pain, hepatomegaly, weight gain and ascites followed by jaundice. The pattern of serum enzyme elevations is usually hepatocellular, with marked increases in serum aminotransferase and lactic dehydrogenase levels and minimal increase in alkaline phosphatase. In severe instances, there are elevations in prothrombin time and progressive hepatic failure. Immunoallergic and autoimmune features are uncommon. The fatality rate is high. Liver biopsy shows centrolobular necrosis and congestion with occlusion of small veins and red cells in sinusoids.

Likelihood score: D (possible, rare cause of clinically apparent liver injury).

### Mechanism of Injury

The potential mechanism of hepatotoxicity from thiotepa is probably similar to that of other alkylating agents, a direct cytotoxic injury to rapidly dividing cells. High doses are likely to injure other cells such as sinusoidal endothelial cells and hepatocytes. The cause of the idiosyncratic liver injury associated with thiotepa is not known.

### Outcome and Management

Liver injury is not uncommon with high doses of thiotepa. The severity of injury in reported cases has generally been mild-to-moderate and self-limited in course, although fatalities attributed to hepatotoxicity have been reported. The sinusoidal obstruction syndrome associated with thiotepa and other alkylating agents can be severe and lead to acute liver failure. There have been no instances of chronic hepatitis or vanishing bile duct syndrome definitely linked to thiotepa therapy. In situations of acute liver injury after thiotepa use, rechallenge should be avoided.

Drug Class: Antineoplastic Agents, Alkylating Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Thiotepa – Generic, Thioplex®

DRUG CLASS

Antineoplastic Agents, Alkylating Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=THIOTEPA)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Thiotepa | 52-24-4 | C6-H12-N3-P-S

## ANNOTATED BIBLIOGRAPHY

References updated: 12 September, 2020

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999; thiotepa has been implicated in at least one case of acute liver failure).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 549-68. (Review of hepatotoxicity of cancer chemotherapeutic agents).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Cytotoxic agents. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1167-201. (Textbook of pharmacology and therapeutics).
Rollins BJ. (1986). Hepatic veno-occlusive disease. Am J Med. (Review of the diagnosis, clinical course, histology and pathogenesis of veno-occlusive disease).
Lazarus HM, Reed MD, Spitzer TR, Rabaa MS, Blumer JL. (1987). High-dose i.v. thiotepa and cryopreserved autologous bone marrow transplantation for therapy of refractory cancer. Cancer Treat Rep. (Among 25 patients with refractory cancers treated with escalating doses of thiotepa followed by autologous bone marrow transplantation, toxicity was dose limiting and 2 had hepatotoxicity, one being fatal, but no details given).
Jones RJ, Lee KS, Beschorner WE, Vogel VG, Grochow LB, Braine HG, Vogelsang GB, et al. (1987). Veno-occlusive disease of the liver following bone marrow transplantation. Transplantation. (Among 235 patients undergoing hematopoietic cell transplantation between 1982 and 1985, sinusoidal obstruction syndrome [SOS] developed in 52 [22%] of whom half died, making SOS the third most common cause of death in this population).
Bearman SI. (1995). The syndrome of hepatic veno-occlusive disease after marrow transplantation. Blood. (Review of SOS after hematopoietic cell transplantation; usually presents with painful hepatomegaly, weight gain [fluid and ascites] and jaundice within 3 weeks of myeloablation with occlusion of central veins and sinusoids and extensive zone 3 [centrolobular] injury).
Przepiorka D, Nath R, Ippoliti C, Mehra R, Hagemeister F, Diener K, Dimopoulos M, et al. (1995). A phase I-II study of high-dose thiotepa, busulfan and cyclophosphamide as a preparative regimen for autologous transplantation for malignant lymphoma. Leuk Lymphoma. (Among 34 patients with lymphoma treated with high dose thiotepa, busulfan and cyclophosphamide with autologous hematopoietic cell transplantation, liver toxicity was common at high doses, 3 developing "centrilobular necrosis" without SOS).
Papadakis V, Dunkel IJ, Cramer LD, Kramer E, Papadopoulos E, Goldman S, Packer RJ, et al. (2000). High-dose carmustine, thiotepa and etoposide followed by autologous bone marrow rescue for the treatment of high risk central nervous system tumors. Bone Marrow Transplant. (Among 42 patients with brain tumors who were treated with high dose carmustine, thiotepa and etoposide and autologous hematopoietic cell transplantation, 2 developed SOS and 5 had transient elevations in ALT levels).
Lee JL, Gooley T, Bensinger W, Schiffman K, McDonald GB. (1999). Veno-occlusive disease of the liver after busulfan, melphalan, and thiotepa conditioning therapy: incidence, risk factors, and outcome. Biol Blood Marrow Transplant. (Among 253 patients who received a regimen of busulfan, melphalan and thiotepa in preparation for hematopoietic stem cell transplantation, 70 [28%] developed SOS, which was severe in 11 and fatal in 9).
DeLeve LD, Shulman HM, McDonald GB. (2002). Toxic injury to hepatic sinusoids: sinusoidal obstruction syndrome. Semin Liver Dis. (Review of clinical features, pathology, etiology, prevention and treatment of sinusoidal obstruction syndrome, a better term for this condition than veno-occlusive disease; first described in association with exposure to phytotoxins [pyrrolizidine alkaloids], the most common cause now is cancer chemotherapy and particularly myeloablative conditioning regimens in preparation for bone marrow transplantation).
McDonald GB. (2010). Hepatobiliary complications of hematopoietic cell transplantation, 40 years on. Hepatology. (Review of liver complications of bone marrow [hematopoietic cell] transplantation, which have become less frequent with better understanding of their causes and means of prevention; the rate of sinusoidal obstruction syndrome has decreased because of avoidance of more aggressive ablative therapies [total body irradiation and high doses of cyclophosphamide] and better understanding of pharmacokinetics of the alkylating agents).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 363 [36%] were attributed to antibiotics, but none were attributed to thiotepa).
Ferreri AJ, Cwynarski K, Pulczynski E, Ponzoni M, Deckert M, Politi LS, Torri V, et al., International Extranodal Lymphoma Study Group (IELSG). (2016). Chemoimmunotherapy with methotrexate, cytarabine, thiotepa, and rituximab (MATRix regimen) in patients with primary CNS lymphoma: results of the first randomisation of the International Extranodal Lymphoma Study Group-32 (IELSG32) phase 2 trial. Lancet Haematol. (Among 219 patients with primary CNS lymphoma treated with methotrexate and cytarabine alone, or combined with rituximab or with rituximab and thiotepa, remission rates and survival were greatest with thiotepa while rates of hepatoxicity were slightly less [35% vs 44%]).
Maximova N, Sonzogni A, Matarazzo L, Ghirardi A, D'Antiga L. (2018). Vanishing bile ducts in the long term after pediatric hematopoietic stem cell transplantation. Biol Blood Marrow Transplant. (Among 47 children undergoing 50 hematopoietic cell transplant [HCT] with various conditioning regimens including thiotepa [n=29], hepatic graft-vs-host disease arose in 12 [24%] overall and long term follow up with liver biopsies found bile duct loss [ductopenia] in 94% which was severe [less than 20% of portal areas with bile ducts] in 74%, slightly higher rates found in those who had received thiotepa).
Sheth V, Nachmias B, Grisariu S, Avni B, Or R, Shapira M. (2019). Augmented myeloablative conditioning with thiotepa in acute myeloid leukemia – improved outcomes with similar toxicity. Leuk Lymphoma. (Among 89 patients with acute myelogenous leukemia undergoing HCT using conditioning regimens with busulfan and fludarabine with or without thiotepa, use of thiotepa was associated with improved 5-year survival [62% vs 38%] and lower relapse rates [8% vs 31%], but similar rates of toxicity including sinusoidal obstruction syndrome [11% vs 18%]).
Duque-Afonso J, Ihorst G, Waterhouse M, Zeiser R, Wäsch R, Bertz H, Yücel M, et al. (2020). Comparison of reduced-toxicity conditioning protocols using fludarabine, melphalan combined with thiotepa or carmustine in allogeneic hematopoietic cell transplantation. Bone Marrow Transplant. (Among 241 patients undergoing HCT for malignant disease using reduced-toxicity conditioning regimens of fludarabine and melphalan with either carmustine [BCNU] or thiotepa, long term survival rates were similar in the two groups as were rates of liver toxicity during the first 30 days [51% vs 49%]).

## OTHER REFERENCE LINKS

1 Recent References on Thiotepa: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Thiotepa/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Thiotepa: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Thiotepa)